# Carbapenems

## OVERVIEW

The carbapenems are beta lactam antibiotics which have a broad spectrum of activity against many gram-positive and gram-negative, aerobic and anaerobic organisms. The carbapenems, like other beta lactam antibiotics, bind to critical penicillin-binding proteins, disrupting the growth and structural integrity of bacterial cell walls. Carbapenems have a fused beta lactam ring that is resistant to most beta lactamases. The carbapenems have excellent activity against streptococci, enterococci, staphylococcci, listeria, enterobacteriaceae, and many pseudomonas, bacteroides and acinetobacter species. However, most methicillin-resistant staphylococci are also resistant to carbapenems. Carbapenems have a safety profile similar to that of other beta lactam antibiotics such as the cephalosporins and the penicillins. The most common adverse effects are injection site reactions, diarrhea, nausea, vomiting, skin rash and pruritus.

The carbapenems (kar" ba pen' ems) that are currently available in the United States (with pronunciation, year of approval and initial brand name) include imipenem (im" i pen' em: 1985, Primaxin), meropenem (mer" oh pen' em: 1996, Merrem), ertapenem (er" ta pen' em: 2001, Invanz) and doripenem (dor" i pen' em: 2008, Doribax). All four agents are poorly absorbed orally and require parenteral administration. Imipenem is given with cilastatin (sye" la stat' in), which inhibits the renal metabolism of imipenem and prolongs its half-life. Imipenem is noted for its dose dependent gastrointestinal side effects as compared to the other carbapenems.

Most carbapenems have been reported to cause transient, mild-to-moderate, and asymptomatic increases in serum aminotransferase levels that rapidly resolve once therapy is stopped. In addition, there have been rare reports of cholestatic liver injury arising during or shortly after carbapenem therapy, often in patients with multiple other medical problems and other causes for liver disease (parenteral nutrition, sepsis). The carbapenems are excreted largely unchanged in the urine with minimal hepatic metabolism, which may be the reason why clinically significant hepatotoxicity with jaundice from the carbapenems is rare.

Each of the carbapenems is discussed separately although references to hepatotoxicity are given together below in this Overview section. The following are links to each specific drug record.

- Doripenem
- Ertapenem
- Imipenem
- Meropenem

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Doripenem | 148016-81-3 | C15-H24-N4-O6-S2
Ertapenem | 153832-46-3 | C22-H25-N3-O7-S | Ertapenem chemical structure
Imipenem | 74431-23-5 | C12-H17-N3-O4-S.H2O | Imipenem chemical structure
Meropenem | 119478-56-7 | C17-H25-N3-O5-S.H2-O | Meropenem chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2017

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 589-637. (Expert review of liver injury due to antimicrobial agents published in 1999, imipenem-cilastin is listed in a table as a cause of serum enzyme elevations only, the other carbapenems are not mentioned).
Moseley RH. Other beta-lactam antibiotics. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced Liver Disease. 3rd edition. Amsterdam: Elsevier, 2013, pp. 466. (Expert review of antibiotic induced liver injury mentions 2 case reports of liver injury from carbapenems).
Petri WA Jr. Penicillins, cephalosporins, and other betalactam antibiotics. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1477-1504. (Textbook of pharmacology and therapeutics).
Calandra GB, Ricci FM, Wang C, Brown KR. Safety and tolerance comparison of imipenem-cilastatin to cephalothin and cefazolin. J Antimicrob Chemother 1983; 12 (Suppl D): 125-31. (Summary of two randomized control trials found AST elevations were more common with imipenem/cilastatin [8 of 208 patients] than with cephalosporins [none of 196]; liver tests were only transiently abnormal and none were associated with symptoms or required drug discontinuation). 6583195
Chiodini PL, Geddes AM, Smith EG, Conlon CP, Farrell ID. Imipenem/cilastatin in the treatment of serious bacterial infections. Rev Infect Dis 1985; 7 (Suppl 3): S490-5. (45 patients given imipenem/cilastatin 2 or 4 g/day four times a day for 1-24 days; phlebitis was common, two adverse events were attributed to therapy–both with mild abnormalities of liver tests, but not explained further). 3901212
Drusano GL, Standiford HC, Bustamante CI, Rivera G, Forrest A, Leslie J, Tatem B, et al. Safety and tolerability of multiple doses of imipenem/cilastatin. Clin Pharmacol Ther 1985; 37: 539-43. (Placebo controlled trial in 12 normal volunteers given imipenem/cilastatin iv for 10 days with laboratory tests pre-, 4 times during and once after; elevated ALT levels occurred in 2 of 6 patients in both groups, but were transient and asymptomatic). 3886256
Calandra GB, Wang C, Aziz M, Brown KR. The safety profile of imipenem/cilastatin: worldwide clinical experience based on 3470 patients. J Antimicrob Chemother 1986; 18 (Suppl E): 193-202. (Combined results of studies in 3470 patients receiving imipenem/cilastatin for up to 14 days; ALT elevations occurred in 5.3%, but most were transient and asymptomatic; 3 patients [0.1%] developed “marked changes in liver function tests and developed icterus during trials of imipenem/cilastatin necessitating its discontinuation. These changes resolved with no long-term sequelae”). 3469194
Garau J, Calandra GB. Intramuscular imipenem/cilastatin in multiple-dose treatment regimens: review of the worldwide clinical experience. Chemotherapy 1991; 37 (Suppl 2): 44-52. (Review of 32 studies in 686 patients of intramuscular imipenem/cilastatin; rates of adverse events were similar to those reported with iv administration, ALT elevations in 1.3%, no mention of clinically apparent liver injury). 1879187
Lami JL, Wilson SE, Hopkins JA. Adjunctive antimicrobials in surgery of soft tissue infections: evaluation of cephalosporins and carbapenems. Am Surg 1991; 57: 769-74. (Trial of meropenem [n=26] vs imipenem [n=26]; one patient on meropenem developed abnormal liver tests without further comment). 1746792
Schreiber C, May B. [Cholestasis in imipenem/cilastatin treatment] Z Gastroenterol 1993; 31 (Suppl 2): 76-7. German. (Abstract only: Cholestatic hepatitis arising after imipenem/cilastatin therapy; resolution in 4 weeks). 7483723
Drusano G. Meropenem: laboratory and clinical data. Clin Microbiol Infect 1997; 3 (Suppl 4): S51-S59. (Review of structure, pharmacology and clinical efficacy of meropenem; similar success rates as with imipenem, cephalosporin-aminoglycoside combinations; no discussion of adverse events). 11869241
Alverez Lerma F, Gil CL. [Clinical experience with meropenem in the treatment of severe infections in critically ill patients.] Rev Esp Quimioter 1998; 11: 229-37. Spanish. (A study of 178 patients who received meropenem for various infections; 2 patients [1%] developed transiently abnormal ALT levels). 9795309
Quattropani C, Schneider M, Helbling A, Zimmermann A, Krähenbühl S. Cholangiopathy after short-term administration of piperacillin and imipenem/cilastatin. Liver 2001; 21: 213-6. ( 20 year old man with severe trauma developed jaundice 2 weeks after a single dose of piperacillin and 3 days of imipenem/cilastatin [bilirubin 0.9 rising to 4.7 mg/dL, ALT 345-669 U/L, Alk P 201 to 599 U/L], resolving over the next 2 months, unclear whether related to piperacillin, cilastatin or imipenem or to sepsis). 11422785
Graham DR, Lucasti C, Malafaia O, Nichols RL, Holtom P, Perez NQ, McAdams A, et al. Ertapenem once daily versus piperacillin-tazobactam 4 times per day for treatment of complicated skin and skin-structure infections in adults: results of a prospective, randomized, double-blind multicenter study. Clin Infect Dis 2002; 34: 1460-8. (Randomized controlled trial of ertapenem vs piperacillin-tazobactam in 540 patients; ALT elevations in 4.3% [40-271 U/L] of ertapenem vs 3.7% [40-271 U/L] in piper/tazo-recipients, all resolving after stopping ertapenem). 12015692
Teppler H, Gesser RM, Friedland IR, Woods GL, Meibohm A, Herman G, Mistry G, et al. Safety and tolerability of ertapenem. J Antimicrob Chemother 2004; 53 (Suppl 2): ii75-81. (Summary of safety studies in 240 healthy volunteers and 2046 patients in Phase II and III trials of ertapenem; side effects were similar to those of comparative agents including ceftriazone and piperacillin/tazobactam; mild-to-moderate ALT elevations occurred in 8.3-8.8% of ertapenem, compared to 6.9-7.3% of comparator-recipients treated for 1 to 28 days; all abnormalities returned to normal in post-therapy follow-up). 15150186
Blumer JL, Saiman L, Konstan MW, Melnick D. The efficacy and safety of meropenem and tobramycin vs ceftazidime and tobramycin in the treatment of acute pulmonary exacerbations in patients with cystic fibrosis. Chest 2005; 128: 2336-46. (Randomized trial of meropenem vs ceftazidime [both with tobramycin] in 121 patients with cystic fibrosis; ALT elevations occurred in 10-12% of patients in both groups; one patient was withdrawn from meropenem because of abnormal ALT, AST and Alk P levels attributed to therapy). 16236892
Zhanel GG, Johanson C, Embil JM, Noreddin A, Gin A, Vercaigne L, Hoban DJ. Ertapenem: review of a new carbapenem. Expert Rev Anti Infect Ther 2005; 3: 23-39. (Extensive review of ertapenem pharmacology, efficacy and safety; largely quotes safety results from Teppler et al. [2004]). 15757455
Linden P. Safety profile of meropenem: an updated review of over 6,000 patients treated with meropenem. Drug Saf 2007; 30: 657-68. (Extensive review of studies of safety of meropenem in phase III studies reported ALT elevations in 5.2% of meropenem recipients [n=6308] compared to 4.2% with cephalosporins, 3.2% with imipenem/cilastatin and 8.2% with clindamycin-aminoglycosides; no mention of hepatitis or jaundice). 17696578
Zhanel GG, Wiebe R, Dilay L, et al. Comparative review of the carbapenems. Drugs 2007; 67: 1027-52. (Review of pharmacology, efficacy and safety of 3 carbapenems “Like other ß-lactams, imipenem/cilastatin, meropenem and ertapenem can affect various laboratory tests including mild-to-moderate, transient increases in hepatic enzymes.”). 17488146
Doripenem (Doribax)--a new parenteral carbapenem. Med Lett Drugs Ther 2008; 50 (1278): 5-7. (Concise review of the antibacterial activity, clinical efficacy, safety and costs of doripenem shortly after its approval in the US; mentions side effects of headaches, nausea, diarrhea, rash, injection site phlebitis and hypersensitivity reactions; no mention of ALT elevations or hepatotoxicity). 18219262
Lucasti C, Jasovich A, Umeh O, Jiang J, Kaniga K, Friedland I. Efficacy and tolerability of IV doripenem versus meropenem in adults with complicated intra-abdominal infection: a phase III, prospective, multicenter, randomized, double-blind, noninferiority study. Clin Ther 2008; 30: 868-83. (Among 476 patients with complicated intraabdominal infections treated with iv doripenem or meropenem, cure rates [86% vs 85%] and adverse event rates [83% vs 78%] were similar, hepatic enzyme elevations occurred in 2 [0.9%] vs 6 [2.5%] patients, and no serious adverse event was considered drug related). 18555934
Réa-Neto A, Niederman M, Lobo SM, Schroeder E, Lee M, Kaniga K, Ketter N, et al. Efficacy and safety of doripenem versus piperacillin/tazobactam in nosocomial pneumonia: a randomized, open-label, multicenter study. Curr Med Res Opin 2008; 24: 2113-26. (Among 448 patients with nosocomial pneumonia treated with iv doripenem or piperacillin/tazobactam for 7 to 14 days, both cure rates and adverse event rates were similar, ALT elevations arising in 1.8% vs 0.9% of patients). 18549664
Chastre J, Wunderink R, Prokocimer P, Lee M, Kaniga K, Friedland I. Efficacy and safety of intravenous infusion of doripenem versus imipenem in ventilator-associated pneumonia: a multicenter, randomized study. Crit Care Med 2008; 36: 1089-96. (Among 531 patients with ventilator associated pneumonia treated wtih doripenem or imipenem for 7-14 days, both response and adverse event rates were similar and "hepatic enzyme increased" was reported in 4.6% on doripenem and 2.3% on imipenem; no mention of clinically apparent liver injury or liver related deaths). 18379232
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, one was linked to imipenem-cilastatin, but was judged as only possibly related, the patient developing elevated Alk P [peak 638 U/L] and bilirubin [2.3 mg/dL] during a bout of alcoholic pancreatitis and while receiving imipenem). 18955056
Redman R, File TM Jr. Safety of intravenous infusion of doripenem. Clin Infect Dis 2009; 49 Suppl 1: S28-35. (Review of safety data from 1817 patients in 7 clinical trials of iv doripenem and 1325 patients receiving comparator drugs, reported similar rates of side effects with doripenem as with other arms; diarrhea in 9%, headache 10%, nausea 8%, phlebitis 6%, rash in 4%, hypersensitivity reacitons 0.7%, ALT elevations 1.1%, jaundice and ALT elevations in 0.8%, but no episodes of acute liver failure). 19619019
Schumaker AL, Okulicz JF. Meropenem-induced vanishing bile duct syndrome. Pharmacotherapy 2010; 30: 335e-338e. (60 year old woman developed jaundice 3 weeks after starting meropenem [bilirubin 11.2 mg/dL, ALT 83 U/L, Alk P 1467 U/L], with biopsy showing bile duct loss and subsequent prolonged jaundice and pruritus). 20812433
Goto M, Shimizu F, Takeo N, Okamoto O, Katagiri K, Ikewaki J, Ogata M, et al. Drug-induced hypersensitivity syndrome due to carbapenem antibiotics. J Dermatol 2010; 37: 374-7. (64 year old man with lymphoma on chemotherapy developed rash, fever, lymphadenopathy and liver injury while on multiple drugs including loxoprofen, SMZ/TMP, ciprofloxacin, zolpidem and meropenem and imipenem-cilastin [bilirubin not given, ALT 148 U/L, Alk P 427 U/L], also associated with CMV and HHV-6 viremia, lymphocyte stimulation tests were positive to carbapenem antibiotics and not to other agents, resolving with prednisone therapy). 20507410
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury but none were due to carbenepenems). 20949552
Chahine EB, Ferrill MJ, Poulakos MN. Doripenem: a new carbapenem antibiotic. Am J Health Syst Pharm 2010; 67: 2015-24. (Review of the chemistry, antibacterial activity, pharmacology, clinical efficacy and safety of doripenem mentions the most common side effects as being heachache, insomnia, gastrointestinal upset, and phlebitis; and, that hepatic enzyme elevations occur in 0.8-4.6% of treated subjects). 21098373
Redman R, Damiao R, Kotey P, Kaniga K, Davies T, Naber KG. Safety and efficacy of intravenous doripenem for the treatment of complicated urinary tract infections and pyelonephritis. J Chemother 2010; 22: 384-91. (Among 799 patients with complicated urinary tract infections treated with iv doripenem and 372 with levofloxacin, both response and adverse event rates were similar; no mention of ALT elevations or hepatotoxicity). 21303745
Tazuma S, Igarashi Y, Inui K, Ohara H, Tsuyuguchi T, Ryozawa S; BTI Therapy Research Group. Clinical efficacy of i.v. doripenem, a new class of carbapenem, in patients with biliary tract infection: A multicenter trial. Hepatol Res 2011; 41: 340-9. (Among 119 patients with acute biliary tract infections treated with iv doripenem for 2-17 days, the response rate was 92% and only 6 patients had adverse events, none were serious, 3 were liver related and 2 led to early withdrawal with subsequent resolution). 21426451
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, Park JW, Hong CS. Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci 2012; 27: 268-73. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including 9 [1.6%] attributed to carbapenems). 22379337
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to carbenepenems). 23419359
Hornik CP, Herring AH, Benjamin DK Jr, Capparelli EV, Kearns GL, van den Anker J, Cohen-Wolkowiez M, et al.; Best Pharmaceuticals for Children Act-Pediatric Trials Network. Adverse events associated with meropenem versus imipenem/cilastatin therapy in a large retrospective cohort of hospitalized infants. Pediatr Infect Dis J 2013; 32: 748-53. (Analysis of adverse event reports from 322 neonatal intensive care units between 1997 to 2010 included reports of ALT elevations above 100 U/L in 2% of imipenem vs 7% of meropenem treated neonates, but there were no liver related severe adverse events).23838776
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18] and nitrofurantoin [n=17]; no carbapenems were listed). 24552865
Cannavino CR, Castaneda-Ruiz B, Redman R, Go O, Cirillo I, Barauskas V, Senatorova G, et al. Safety and tolerability of doripenem in hospitalized children With complicated intra-abdominal infection, complicated urinary tract infections and pneumonia. Pediatr Infect Dis J 2015; 34: 1264-7. (Among 88 children with severe bacterial infections treated with iv doripenem or a comparator antibiotic, serious adverse event rates were similar and ALT elevations occurred in 3 of 66 [4.5%] vs none of 22 [0%], but none developed clinically apparent liver injury). 26226440
Tazuma S, Igarashi Y, Inui K, Ohara H, Tsuyuguchi T, Ryozawa S; BTI Therapy Research Group. Clinical efficacy of intravenous doripenem in patients with acute biliary tract infection: a multicenter, randomized, controlled trial with imipenem/cilastatin as comparator. J Gastroenterol 2015; 50: 221-9. (Among 127 patients with acute biliary tract infections treated with doripenem [D] or imimpenem/cilastatin [I/C] for 3-21 days, response rates were similar and the only adverse drug reactions were watery diarrhea [D], hypersensivity rash [D] and pseudomembraneous colitis [I/C] in one patient each, no mention of ALT elevations). 24795092
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics, but only one to a carbapenem [meropenem]). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Carbapenems: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Carbapenems+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Carbapenems: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=carbapenems)